# Penbutolol

## OVERVIEW

### Introduction

Penbutolol is a nonselective beta-adrenergic receptor blocker (beta-blocker) used for the therapy of hypertension. Penbutolol has yet to be convincingly associated with clinically apparent liver injury.

### Background

Penbutolol (pen bue' toe lol) is a nonselective beta-blocker, acting on both beta-1 and beta-2 adrenergic receptors. Beta-1 adrenergic blockade reduces the heart rate and myocardial contractility by slowing the AV conduction and suppressing automaticity. Beta-2 blockade affects peripheral vascular resistance and can cause bronchospasm and hypoglycemia. Penbutolol also has mild sympatheticomimetic activity acting as a partial beta-adrenergic receptor agonist. Penbutolol is indicated for the management of hypertension and was approved for use in the United States in 1987. Penbutolol is available in tablets of 20 mg under the trade name Levatol. The typical initial oral dose of penbutolol in adults is 20 mg once daily, with subsequent dose modification based upon clinical response and tolerance, the average total daily maintenance dose being 20 to 60 mg. Common side effects of penbutolol include bradycardia, hypotension, fatigue, dizziness, depression, memory loss, impotence, cold limbs and, less commonly, severe hypotension, heart failure and bronchospasm. Sudden withdrawal can trigger rebound hypertension. Beta-blockers are contraindicated in patients with asthma, bradycardia and heart failure and should be used cautiously in the elderly and in patients with diabetes.

### Hepatotoxicity

Mild-to-moderate elevations in serum aminotransferase levels occur in less than 2% of patients on penbutolol and are usually transient and asymptomatic, resolving even with continuation of therapy. Despite its wide spread use, penbutolol has not been convincingly linked to instances of clinically apparent liver injury. Other beta-blockers have been linked to rare instances of acute liver injury with a latency to onset of 4 to 24 weeks, a hepatocellular pattern of serum enzyme elevations and a rather mild, self-limiting course without evidence of hypersensitivity or autoimmune reactions.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Penbutolol undergoes extensive metabolism by the liver and is excreted in the urine as inactive metabolites. The reason why penbutolol rarely causes liver injury is unknown; other beta-blockers with similar chemical structures have been linked to cases of clinically apparent, idiosyncratic liver injury.

References to the safety and potential hepatotoxicity of penbutolol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Penbutolol – Levatol®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Penbutolol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Penbutolol | 38363-40-5 | C18-H29-N-O2 | Penbutolol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Penbutolol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Penbutolol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Penbutolol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Penbutolol)